# Antiarrhythmic Agents

## OVERVIEW

The antiarrhythmics are a heterogeneous group of medications that act to decrease cardiac automaticity and slow conduction, and are used for either or both ventricular and atrial arrhythmias. The most common use of antiarrhythmics is in the treatment of atrial fibrillation or flutter, or prevention of their recurrence in patients after electrical or medical cardioversion. Use of antiarrhythmics for suppression of ventricular arrhythmias is controversial in that several studies have shown that suppression of ventricular premature contractions can be associated with a decrease rather than increase in survival. Thus, the antiarrhythmics are generally used only for clinically significant ventricular dysrrhythmias.

The oral antiarrhythmics are often separated into classes based upon their major molecular target as either class I (sodium channel), II (beta adrenergic receptor), III (potassium channel), or IV (calcium channel). Many agents have multiple targets, but the classification is helpful particularly because of shared side effects.

Oral antiarrhythmics available in the United States (and their year of approval) include quinidine (1950), procainamide (1950), disopyramide (1977), amiodarone (1985), flecainide (1985), mexiletine (1985), propafenone (1989) and dronedarone (2009). Agents used intravenously, usually for a short period only with severe arrhythmias, include adenosine (1989), ibutilide (1995), isoproterenol (1992) and dofetilide (2000). Agents used to slow atrial-ventricular conduction include cardiac glycosides (digoxin, digitoxin), calcium channel blockers (diltiazem, verapamil), and beta adrenergic blockers (esmolol, propranolol, and sotalol) which are discussed elsewhere.

Amiodarone is a well established cause of drug induced liver injury and can cause both an acute as well as a chronic liver injury with cirrhosis. Dronedarone, a non-iodinated derivative of amiodarone, has been implicated in several cases of severe acute liver failure and may share the propensity for hepatotoxicity of amiodarone. The other antiarrhythmics are rare causes of liver injury, their cardiac and central nervous system adverse events usually overshadowing the idiosyncratic effects on the liver. General references are provided after this introduction and specific references on hepatotoxicity are given after the description of each of the following agents:

- Amiodarone
- Disopyramide
- Dofetilide
- Dronedarone
- Flecainide
- Ivabradine
- Mexiletine
- Procainamide
- Propafenone
- Quinidine

## ANNOTATED BIBLIOGRAPHY

References updated: 06 July 2017

Zimmerman HJ. Antiarrhythmics. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 642-4. (Expert review of hepatotoxicity published in 1999; among the antiarrhythmics, only amiodarone and quinidine are common causes of hepatotoxicity; quinidine has been associated with many cases of clinically apparent, but mild liver injury usually with signs of hypersensitivity and hepatic granulomas; disopyramide has been linked to at least 10 cases of drug induced liver disease, mexiletine to 6 cases, and propafenone and flecainide to rare cases of cholestatic jaundice).
De Maurzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 519-40. (Review of hepatotoxicity of antiarrhythmics with specific discussion of amiodarone, dronedarone, procainamide, quinidine, and propafenone).
Sampson KJ, Kass RS. Anti-arrhythmic drugs. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 815-48. (Textbook of pharmacology and therapeutics).
Koch-Weser J. Disopyramide. N Engl J Med 1979; 300: 957-62. (Review of disopyramide; mechanism of action is unclear, myocardial depressant and has anticholinergic activity which accounts for side effects of urinary retention, visual blurring, constipation and nausea. Acute psychoses, cholestatic jaundice, hypoglycemia and agranulocytosis have occurred in rare patients). 431563
Scheinman SJ, Poll DS, Wolfson S. Acute cardiac failure and hepatic ischemia induced by disopyramide phosphate. Yale J Biol Med 1980; 53: 361-6. (2 patients developed heart failure and raised serum enzymes within 1-2 days of starting disopyramide [AST rising to 4780 and 1495 U/L, bilirubin peak 2.1 mg/dL, Alk P normal], resolving within 7-8 days). 7222741
Arif M, Laidlaw JC, Oshrain C, Willis PW 3rd, Nissen CH, McDermott DJ, Smith WS, et al. A randomized, double-blind, parallel group comparison of disopyramide phosphate and quinidine in patients with cardiac arrhythmias. Angiology 1983; 34: 393-400. (124 patients with ventricular arrhythmias received disopyramide or quinidine for 8 weeks; AST elevations occurred in 3 on quinidine and 1 on disopyramide but none had symptoms or jaundice). 6408949
Libersa C, Caron J, Pladys A, Beuscart R, Kacet S, Wajman A, Connell C, et al. Propafenone versus disopyramide: a double-blind randomized crossover trial in patients presenting chronic ventricular arrhythmias. Clin Cardiol 1987; 10: 405-10. (Ten patients with ventricular arrhythmias were treated with disopyramide vs propafenone vs placebo in a crossover study for 6 days each; no change in chemical parameters). 2440632
Propafenone for cardiac arrhythmias. Med Lett Drugs Ther 1990; 32: 37-8. (Short summary of efficacy and safety of propafenone published soon after its approval in the US; adverse effects include dizziness, change in taste, blurred vision, abdominal discomfort, anorexia, and nausea; can worsen heart failure; no mention of hepatic adverse effects). 2182990
Flecainide for supraventricular tachyarrhythmias. Med Lett Drugs Ther 1992; 34: 71-2. (Short summary of efficacy and safety of flecainide published soon after its approval in the US; adverse effects include dizziness and blurred vision, but recommended restricted use because of its proarrhythmic effects). 1630411
Echt DS, Liebson PR, Mitchell LB, Peters RW, Obias-Manno D, Barker AH, Arensberg D, et al. Mortality and morbidity in patients receiving encainide, flecainide, or placebo. The Cardiac Arrhythmia Suppression Trial. N Engl J Med 1991; 324: 781-8. (Among 1498 patients with myocardial infarction and ventricular ectopy, 323 were treated with flecainide and 318 to placebo and followed for a mean of 10 months; there was an excess mortality from cardiac arrest in antiarrhythmic treated patients; no mention of hepatotoxicity or ALT elevations). 1900101
Roden DM. Antiarrhythmic drugs: from mechanisms to clinical practice. Heart 2000; 84: 339-46. (Overview of antiarrhythmic drugs which are separated in four classes based upon molecular target: I being sodium channel blockers; II beta blockers; III potassium channel blockers, and IV calcium channel blockers; some agents having multiple targets). 10956304
McNamara RL, Tamariz LJ, Segal JB, Bass EB. Management of atrial fibrillation: review of the evidence for the role of pharmacologic therapy, electrical cardioversion, and echocardiography. Ann Intern Med 2003; 139: 1018-33. (Systematic review of literature on efficacy and safety of medications for atrial fibrillation; no discussion of hepatic side effects). 14678922
Drugs for cardiac arrhythmias. Treat Guidel Med Lett 2007; 5: 51-8. (Concise review of drugs for arrhythmias). 17505408
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 2 cases were attributed to amiodarone and 1 to propafenone, but none to other antiarrhythmics such as quinidine, procainamide, disopyramide, flecainide, or mexiletine). 18955056
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, none of which were attributed to an antiarrhythmic agent). 20949552
Treatment of atrial fibrillation. Treat Guidel Med Lett 2010; 8 (97): 65-70; (Concise review of efficacy and safety of drugs for atrial fibrillation including amiodarone, disopyramide, dofetilide, dronedarone, flecainide, propafenone, and sotalol; only amiodarone, dronedarone and propafenone are listed as having adverse effects of hepatotoxicity). 20733547
Safety of dronedarone (Multaq). Med Lett Drugs Ther 2011; 53 (1379-1380): 103-4. (Concise review of adverse effects of dronedarone, which include hepatotoxicity and an increased risk of death from cardiovascular causes). 22173456
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, one of which was due to amiodarone, but in no other case was an antiarrhythmic agent implicated). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, 2 of which were attributed to propafenone, but none to amiodarone or dronedarone). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 7 were attributed to antiarrhythmic agents including 5 due to amiodarone and 2 to dronedarone). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Antiarrhythmic Agents: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(antiarrhythmics/AE+NOT+clavulanic+acid)+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Antiarrhythmic Agents: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=antiarrhythmics)